# Chloral hydrate

## OVERVIEW

### Introduction

Chloral hydrate is a mild hypnotic that is used to treat simple insomnia. Despite many years of use, chloral hydrate has not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

Chloral hydrate is a hypnotic agent that was developed in the 19th century and was commonly used as a sleeping aid into the 1970s, when it was replaced by the benzodiazepines. Chloral hydrate is a simple chlorinated molecule that is converted in the liver (by alcohol dehydrogenase) to trichloroethanol, which is the active moiety. Chloral hydrate has been used to treat simple insomnia and formerly was prescribed for a large proportion of hospitalized patients on a "as needed" basis. Tolerance to the hypnotic activity of chloral hydrate develops rapidly, and it is recommended for short term use only. Residual somnolence is not infrequent, and prolonged use can lead to physical dependence and withdrawal agitation and insomnia. Furthermore, overdose of chloral hydrate can cause respiratory depression and death. Because of the availability of safer and more effective medications for insomnia, chloral hydrate is now rarely used. Current indications are for short term management of simple insomnia. An off-label use has been sedation in children undergoing diagnostic, dental or anxiety provoking procedures. Chloral hydrate is available generically in 500 mg capsules. The recommended dose is 500 to 1,000 mg taken orally 15 to 30 minutes before going to bed. Chloral hydrate is classified as a schedule IV controlled substance (low potential for abuse and for limited physical or psychological dependence) and is now rarely used. Side effects include daytime somnolence, fatigue, dizziness, confusion, ataxia and headache.

### Hepatotoxicity

Chloral hydrate has been in clinical use for many decades and has not been linked to serum enzyme elevations during therapy or instances of clinically apparent liver injury. While prospective studies of the effects of chloral hydrate on liver tests have not been done, the absence of reported instances of liver injury attributable to chloral hydrate suggests that it has little or no hepatic toxicity. Chloral hydrate has been linked to hypersensitivity reactions such as rash, fever and eosinophilia. Chloral hydrate also has major drug-drug interactions with oral anticoagulants, antidepressants and alcohol. In patients with cirrhosis and hepatic decompensation, chloral hydrate can trigger or worsen hepatic encephalopathy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Sedatives and Hypnotics, Miscellaneous

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chloral Hydrate – Generic

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Chloral+Hydrate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chloral Hydrate | 302-17-0 | C2-H3-Cl3-O2 | Chloral Hydrate Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 23 January 2017

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; several hypnotics are discussed, but not chloral hydrate).
Mihic SJ, Harris RA. Hypnotics and sedatives. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 457-80. (Textbook of pharmacology and therapeutics).
Miller RR, Greenblatt DJ. Clinical effects of chloral hydrate in hospitalized medical patients. J Clin Pharmacol 1979; 19: 669-74. (Among 26,294 patients admitted to 22 Boston hospitals between 1966 and 1975, 5435 [21%] received chloral hydrate, usually "as needed" for insomnia, of whom 119 [2.2%] had adverse events which were mostly drowsiness, depression and gastrointestinal upset; 19 had hypersensitivity reactions [rash, fever, eosinophilia]; and 3 had hepatic decompensation [asterixis, coma]). 512063
Linnoila M, Viukari M, Numminen A, Auvinen J. Efficacy and side effects of chloral hydrate and tryptophan as sleeping aids in psychogeriatric patients. Int Pharmacopsychiatry 1980; 15: 124-8. (Controlled trial of chloral hydrate vs tryptophan vs placebo in 19 women in a "psychogeriatric" hospital found chloral hydrate more effective than both placebo and tryptophan, with no side effects except withdrawal insomnia lasting ~3 nights). 7002832
Piccione P, Zorick F, Lutz T, Grissom T, Kramer M, Roth T. The efficacy of triazolam and chloral hydrate in geriatric insomniacs. J Int Med Res 1980; 8: 361-7. (Double blind cross over study of triazolam vs chloral hydrate vs placebo in 27 patients with insomnia; sleep latency and total sleep time were no better with chloral hydrate than placebo; there were few side effects with either chloral hydrate or placebo). 6106611
Bain KT. Management of chronic insomnia in elderly persons. Am J Geriatr Pharmacother. 2006; 4: 168-92. (Review of treatment of insomnia in the elderly; chloral hydrate fell out of favor in the 1970s when it was replaced by the benzodiazepines; problems include gastrointestinal intolerance, rapid tolerance, drug-drug interactions, and fatalities from overdose). 16860264
Drugs for insomnia. Treat Guidel Med Lett 2012; 10 (119): 57-60. (Guidelines for therapy of insomnia; mentions that chloral hydrate is effective hypnotic for transient insomnia when used for a few nights only, but it can lead to physical dependence and withdrawal can cause disrupted sleep and nightmares). 22777275
West SK, Griffiths B, Shariff Y, Stephens D, Mireskandari K. Utilisation of an outpatient sedation unit in paediatric ophthalmology: safety and effectiveness of chloral hydrate in 1509 sedation episodes. Br J Ophthalmol 2013; 97: 1437-42. (Retrospective study of 1509 episodes of sedation with chloral hydrate in children from 2006-2011 found that 97% were successful and there were no serious complications, adverse events being paradoxical arousal or irritability [1.3%], oxygen desaturation [1%] and vomiting [0.5%]; no mention of hepatic injury). 24045857
Sezer T, Alehan F. Chloral hydrate versus hydroxyzine HCL for sedation prior to pediatric sleep EEG recording. Int J Neurosci 2013; 123: 719-23. (Controlled trial of chloral hydrate vs hydoxyzine for sedation in children undergoing EEG recording found chloral hydrate more effective while side effects were similar [oxygen desaturation, irritability, vomiting], with no mention of liver complications). 23594140
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, none were attributed to a sleeping aid, sedate or hypnotic or to chloral hydrate). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Chloral Hydrate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Chloral+Hydrate/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Chloral Hydrate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chloral+Hydrate)